# Hereditary Angioedema Agents

## OVERVIEW

### Introduction

Multiple parenterally administered agents are available as prophylaxis or treatment of acute attacks of hereditary angioedema (HAE), including plasma derived and recombinant preparations of the C1-esterase Inhibitor as well as small protein and monoclonal antibody inhibitors of kallikrein and bradykinin activity. While several of these have been linked to transient serum aminotransferase elevations during therapy, the abnormalities are usually mild-to-moderate in severity, transient in duration, and sometimes due to the underlying condition rather than the treatment. None of the agents used to prevent or treat acute attacks of HAE have been convincingly implicated in cases of acute liver injury with symptoms or jaundice.

### Background

Hereditary angioedema (HAE) is an autosomal dominant condition caused by mutations in the gene that encodes C1-esterase inhibitor and is marked clinically by intermittent episodes of moderate-to-severe swelling and pain affecting the gastrointestinal tract, genitourinary tract, skin, hands, feet, face, or larynx. The attacks are intermittent and unpredictable and can be disabling although usually self-limited, lasting hours or a few days. Most critical are attacks of laryngeal edema that can result in airway compromise and fatal respiratory failure. HAE is caused by mutations in the SERPIN-G1 gene that encodes the C1-esterase inhibitor that is important in regulation of kallikrein and release of bradykinin. Elevated bradykinin levels cause an increase in vascular permeability resulting in the swelling and pain of acute attacks. Several medications have been developed for prophylaxis against or treatment of acute attacks (Table), including human plasma derived (Cinryze, Haegarda, Berinert) and recombinant C1-esterase inhibitors (Ruconest). These require parenteral administration and are only partially effective in preventing attacks. Also available are small protein or polypeptide inhibitors of the kallikrein pathway (Kalbitor: ecallantide, and Firazyr: icatibant) and monoclonal antibodies to kallikrein (Takhzyro: lanadelumab). These therapies are all given parenterally either at the time of an acute attack or chronically to prevent attacks. While sometimes associated with serum aminotransferase elevations, the enzyme abnormalities are generally mild-to-moderate in severity, and more likely due to the underlying acute attack or comorbidities associated with HAE and its chronic therapy.

Berotralstat, an orally available agent used to prevent acute attacks of HAE, is a small molecule inhibitor of bradykinin and was approved for use in preventing acute attacks of HAE in 2020. It is not considered effective as therapy of acute attacks of HAE. It is described in a separate chapter of LiverTox: Berotralstat.

Danazol is a weak androgenic steroid that was previously used off-label to decrease HAE attacks, but is now rarely employed.

### Hepatotoxicity

Cinryze is the proprietary name for a human plasma derived preparation of C1-esterase inhibitor that was approved for prevention of acute attacks of HAE in 2008 and remains available as a lyophilized powder for reconstitution in single use vials of 500 IU. The recommended dose for adults and adolescents is 1000 IU intravenously every 3 to 4 days (twice weekly). For children ages 6 to 11 years the dose is 500 IU intravenously every 3 to 4 days. Common adverse events include infusion reactions, headache, nausea and vomiting, rash, and fever. Potentially serious but uncommon adverse events include hypersensitivity reactions, an increased risk of arterial and venous thromboembolic events, and the potential of viral transmission because the protein is purified from human plasma that might harbor an infectious agent despite screening of the plasma and the purification process. The product label of Cinryze does not mention ALT elevations or hepatotoxicity and controlled trials and observational studies do not mention hepatic adverse events. Since its approval, there have been no published reports of drug induced liver injury attributed to Cinryze.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Haegarda is the proprietary name for a human plasma derived preparation of C1-esterase inhibitor that was approved for prophylaxis of acute attacks of HAE in 2017 and is available as a lyophilized powder for reconstitution in single use vials of 2000 or 3000 IU. The recommended dose for both adults and children 6 years of age and older is 60 IU/kg subcutaneously twice weekly (every 3 to 4 days). Common adverse events include injection site reactions, hypersensitivity, nasopharyngitis, and dizziness. Potentially serious but uncommon adverse events include severe hypersensitivity reactions, increased risk for arterial and venous thromboembolic events, and the potential risk of viral transmission because the protein is purified from human plasma that might harbor infectious agents despite screening of the plasma and the purification process. The product label of Haegarda does not mention ALT elevations or hepatotoxicity and controlled trials and observational studies do not mention hepatic adverse events. Since its approval and more widescale use there have been no published reports of drug induced liver injury attributed to Haegarda. There have been no reports of transmission of viral agents ascribed to Haegarda thus far.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Berinert is the proprietary name for a human plasma derived preparation of C1-esterase inhibitor that was approved for the treatment of acute attacks of HAE in 2009 and is available as a freeze-dried powder for reconstitution in single use vials of 500 IU. The recommended dose for both adults and children is 20 IU/kg body weight intravenously once for each acute attack. Common adverse events include injection site reactions, dysgeusia, headache, and abdominal discomfort. Potentially serious but uncommon adverse events include severe hypersensitivity reactions, increased risk of arterial and venous thromboembolic events, and the potential risk of viral transmission because the protein is purified from human plasma that might harbor an infectious agent despite screening of the plasma and the purification process. The product label of Berinert does not mention ALT elevations or hepatotoxicity, and controlled trials and observational studies do not mention hepatic adverse events. Since its approval and more widescale use there have been no published reports of drug induced liver injury attributed to Berinert. There have been no reports of transmission of viral agents ascribed to Berinert thus far.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Ruconest is the proprietary name for a recombinant, human C1-esterase inhibitor that was approved for treatment of adults and adolescents with acute attacks of HAE in 2014 and is available as a lyophilized powder for reconstitution in single dose vials of 2100 U. The recombinant protein is produced in transgenic rabbits that secrete the protein in milk. The recommended dose is 50 U per kg body weight if less than 84 kg and 4200 U if body weight is 84 kg or greater given as an intravenous infusion upon recognition of an HAE attack. The first dose should be given by a qualified healthcare professional, but patients can be trained in how to self-administer the infusions so that they can be given with the first evidence of an acute attack. Common adverse events include hypersensitivity reactions, headache, nausea and diarrhea. Potentially serious but uncommon adverse events include severe hypersensitivity reactions, including anaphylaxis, and an increased risk of arterial and venous thromboembolic events. Subsequent to its approval and more widescale use, there have been no published reports of clinically apparent liver injury attributed to Ruconest.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Kalbitor is the proprietary name for ecallantide, a 60 amino acid protein inhibitor of plasma kallikrein that was approved for treatment of acute attacks of HAE adults or children 12 years of age or older in 2009 and is available as a solution for subcutaneous injection in single use glass vials of 10 mg/mL. The recommended dose is 30 mg (three 10 mL subcutaneous injections) which can be repeated once within a 24 hour period, if necessary. The usual regimen is a single injection [more than 90%] and few have required more than two injections. Common adverse events of ecallantide therapy include injection site reactions, hypersensitivity reactions, headache, nausea, diarrhea, fever, and nasopharyngitis. Rare but potentially severe adverse reactions include severe hypersensitivity reactions including anaphylaxis for which reason it should be administered only by a healthcare professional with appropriate medical support to manage anaphylaxis. Because ecallantide is a recombinant protein, it is metabolized by proteolytic enzymes to smaller peptides or amino acids and not by hepatic cytochrome P450 isoenzymes. Hypersensitivity reactions are likely due to non-human source of the recombinant protein. The product label for ecallantide does not mention ALT elevations or hepatotoxicity. Subsequent to the approval of ecallantide, there have been no published reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Firazyr is the proprietary name for icatibant, a synthetic decapeptide inhibitor of the bradykinin B2 receptor that was approved for treatment of adults with acute attacks of HAE in 2011 and is available in solution in prefilled single dose syringes of 30 mg in 3 mL (10 mg/mL). The recommended dose is 30 mg subcutaneously with subsequent injections at least 6 hours apart and no more than 3 injections per day. The usual regimen is a single 30 mg dosage [more than 90%] and few are for more two 30 mg injections. Common adverse events of icatibant therapy include injection site reactions and, less commonly, rash, fever, and dizziness. Icatibant is metabolized by intracellular proteolytic enzymes and does not involve the hepatic cytochrome P450 system. Despite this, elevations in serum aminotransferase levels arose in 4% of patients enrolled in preregistration studies but were usually mild, invariably self-limited in course, not associated with bilirubin elevations, and not requiring dose modification or discontinuation. There were no severe adverse events that were attributed to icatibant therapy. Subsequent to the approval of icatibant in 2011, there have been no published reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Takhzyro is the proprietary name for lanadelumab a human monoclonal antibody to plasma kallikrein that was approved for prophylaxis of acute attacks of HAE in 2018 and is available in solution in a prefilled single dose syringe of 150 mg in 1 mL and 300 mg in 2 mL, as well as in vials of 300 mg in 2 mL. The recommended dose for adults and children above the age of 12 years is 300 mg subcutaneously every 2 or 4 weeks. The dose for children between 2 and 12 years of age is 150 mg subcutaneously every 2 or 4 weeks. Common adverse events include injection site reactions, hypersensitivity, nasopharyngitis, headache, rash, diarrhea, myalgia, and dizziness. Potentially serious but uncommon adverse events include severe hypersensitivity reactions. In preregistration trials in HAE, serum aminotransferase elevations arose in 2% of lanadelumab treated subjects vs 0% of placebo recipients. The aminotransferase elevations were transient and asymptomatic and not accompanied by symptoms or jaundice. Since its approval and more widespread use, there have been no reports of clinically apparent liver injury attributed to lanadelumab. Lanadelumab is described in a separate chapter in LiverTox: Lanadelumab.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Agent | Brand Name | Indication | Route | Adult Dose | Frequency
C1-Esterase Inhibitor (plasma) | Cinryze | Prevention | iv | 1000 IU | Twice weekly
C1-Esterase Inhibitor (plasma) | Haegarda | Prevention | sc | 60 IU/kg | Twice weekly
C1-Esterase Inhibitor (plasma) | Berinert | Treatment | iv | 20 IU/kg | Once
C1-Esterase Inhibitor (recomb) | Ruconest | Treatment | iv | 50 U/kg | Once
Ecallantide (kallikrein inhibitor) | Kalbitor | Treatment | sc | 30 mg | Once
Icatibant (bradykinin B2 R inhibitor) | Firazyr | Treatment | sc | 30 mg | Once
Berotralstat (kallikrein inhibitor) | Orladeyo | Prevention | oral | 150 mg | Daily
Lanadelumab (mab kallikrein) | Takhzyro | Prevention | sc | 300 mg | Every 2 weeks

### Outcome and Management

The product labels for the various parenteral therapies of acute attacks of HAE do not recommend monitoring of routine liver tests during therapy, but testing HAE patients before starting long term prophylaxis therapy is appropriate because of the frequency of comorbidities including liver disease in patients with HAE. Rise in serum aminotransferase levels during therapy should trigger evaluation for other possible causes. Persistence of unexplained ALT levels above 5 times the ULN or appearance of symptoms of liver injury or jaundice should lead to at least temporary discontinuation and more careful monitoring.

Drug Class: Genetic Disorder Agents

Other Drugs for HAE: Berotralstat, Danazol, Lanadelumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Human Plasma Derived C1-Esterase Inhibitor – Cinryze®

Human Plasma Derived C1-Esterase Inhibitor – Haegarda®

Human Plasma Derived C1-Esterase Inhibitor – Berinert®

Human Recombinant C1-Esterase Inhibitor – Ruconest®

Ecallantide – Kalbitor®

Icatibant – Firazyr®

Berotralstat – Orladeyo®

Lanadelumab – Takhzyro®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cinryze), Cinryze®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Haegarda), Haegarda®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Berinert), Berinert®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ruconest), Ruconest®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Kalbitor), Kalbitor®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Firazyr), Firazyr®

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
C1-Esterase Inhibitor | 80295-38-1 | Protein | Not Available
Ecallantide | 460738-38-9 | C305-H442-N88-O91-S8
Icatibant | 138614-30-9 | C59-H89-N19-O13-S
Lanadelumab | 1426055-14-2 (https://pubchem.ncbi.nlm.nih.gov/substance/381127378) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 20 June 2024

Abbreviations: HAE, hereditary angioedema; ULN, upper limit of the normal range.

Skidgel RA. Histamine, bradykinin, and their antagonists. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 711-26. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. 2009. Kalbitor (Ecallantide). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2009/125277s000MedrR_P1.pdf (FDA Summary of the data on the safety and efficacy of ecallantide submitted in support of the application for approval as treatment of acute attacks of HAE, discusses tolerance in 187 patients with HAE among whom 10 [4%] had anaphylactic reactions, often after repeated doses but none were fatal; no mention or discussion of ALT elevations or hepatic adverse events).
FDA. Integrated Review. 2017. Takhzyro (Lanadelumab). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/761090Orig1s000MultidisciplineR.pdf (FDA Summary of the data on the safety and efficacy of lanadelumab submitted in support of the application for its approval for prevention of attacks of HAE, mentions that ALT elevations above 3 times ULN arose in 5 of 84 [6%] subjects treated with lanadelumab, arising after 1 month of treatment with no clear pattern which were invariably transient and not associated with symptoms or jaundice, although leading to early discontinuation in one patient [peak ALT 142 U/L] with obesity and pre-existent minor ALT and AST elevations).
FDA. Integrated Review. 2017. Firazyr (Icatibant). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2011/022150Orig1s000MedR.pdf (FDA Summary of the data on the safety and efficacy of icatibant submitted in support of the application for its approval for therapy of acute attacks of HAE, mentions that there were no clinically significant changes in laboratory values from baseline [pretreatment] to the end of the 14-day observation period; one subject had an ALT elevation to 246 U/L before receiving icatibant for a second attack of HAE, which ultimately resolved after therapy of the attack).
FDA. Integrated Review. 2020. Orladeyo (Berotralstat). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214094Orig1s000MultidisciplineR.pdf (FDA Summary of the data on the safety and efficacy of berotralstat, submitted in support of the application for approval as means of prevention of acute attacks of hereditary angioedema [HAE], mentions that ALT elevations were more frequent with placebo [10%] than berotralstat [2.4% to 5.1%], although one patient on drug developed ALT elevations of above 5 times the upper limit of normal [ULN] and discontinued treatment with prompt resolution; no serious hepatic adverse events or liver injury with jaundice).
Levy RJ, Lumry WR, McNeil DL, Li HH, Campion M, Horn PT, Pullman WE. EDEMA4: a phase 3, double-blind study of subcutaneous ecallantide treatment for acute attacks of hereditary angioedema. Ann Allergy Asthma Immunol. 2010;104:523-9. (Among 96 patients with HAE treated with ecallantide or placebo for a moderate-to-severe acute attack, mean symptom scores improved more quickly with drug than placebo and adverse events were less frequent with ecallantide [17% vs 40%] that included nausea, headache, dizziness and abdominal pain, symptoms typical of attacks of HAE, while “no clinically significant changes were seen regarding…clinical laboratory test results”). 20568386
Sheffer AL, Campion M, Levy RJ, Li HH, Horn PT, Pullman WE. Ecallantide (DX-88) for acute hereditary angioedema attacks: integrated analysis of 2 double-blind, phase 3 studies. J Allergy Clin Immunol. 2011;128:153-159.e4. (Combined analysis of two controlled trials of ecallantide vs placebo in 168 patients with an acute attack of HAE found similar rates of total and severe adverse events in the two groups [36% vs 35% and 3.0% vs 3.7%], and no patient had an anaphylactic or severe hypersensitivity reaction and there were no “clinically relevant changes in… hepatic function”). 21481442
Lumry WR, Li HH, Levy RJ, Potter PC, Farkas H, Moldovan D, Riedl M, et al. Randomized placebo-controlled trial of the bradykinin B_2_ receptor antagonist icatibant for the treatment of acute attacks of hereditary angioedema: the FAST-3 trial. Ann Allergy Asthma Immunol. 2011;107:529-37. (Among 88 patients with an acute attack of HAE treated with icatibant [30 mg] or placebo subcutaneously, the time to improvement and resolution of attacks was shortened by icatibant, while adverse event rates were lower than with placebo [41% vs 52%] and there were no serious adverse events or discontinuations; one patient in each group had a transient ALT elevation but there were “no clinically related changes in laboratory safety” findings). 22123383
Zuraw BL, Kalfus I. Safety and efficacy of prophylactic nanofiltered C1-inhibitor in hereditary angioedema. Am J Med. 2012;125:938.e1-7. (Open label study of Cinryze [human plasma C1 inhibitor: 1000 IU] given every 3 to 7 days for up to 2.6 years in 146 patients with HAE resulted in a 94% reduction in numbers of acute attacks with mostly mild-to-moderate adverse events, none resulting in discontinuation and no serious adverse events attributed to therapy; no mention of ALT elevations or hepatotoxicity). 22800873
Baş M, Greve J, Hoffmann TK, Reshef A, Aberer W, Maurer M, Kivity S, et al. Repeat treatment with icatibant for multiple hereditary angioedema attacks: FAST-2 open-label study. Allergy. 2013;68:1452-9. (Among 54 patients in a controlled trial of icatibant for acute attacks of HAE enrolled in a open-label extension study, repeat treatments [30 mg subcutaneously] yielded similarly shortened times to resolution and while all patients had injection site reactions, there were no clinically relevant changes in safety laboratory measures). 24111645
Riedl MA, Bernstein JA, Li H, Reshef A, Lumry W, Moldovan D, Farkas H, et al.; Study 1310 Investigators. Recombinant human C1-esterase inhibitor relieves symptoms of hereditary angioedema attacks: phase 3, randomized, placebo-controlled trial. Ann Allergy Asthma Immunol. 2014;112:163-169.e1. (Among 75 patients with an acute attack of HAE treated with recombinant C1-esterase inhibitor [Ruconest: 50 IU/kg to maximum of 4200 IU] or placebo, the time to resolution of symptoms was shorter with Ruconest while adverse events were less with treatment and “there were no clinically significant changes from baseline” in any biochemistry values). 24468257
Riedl MA, Bygum A, Lumry W, Magerl M, Bernstein JA, Busse P, Craig T, et al.; Berinert Registry investigators. Safety and usage of C1-inhibitor in hereditary angioedema: Berinert Registry Data. J Allergy Clin Immunol Pract. 2016;4:963-71. (Among 296 patients with HAE treated with subcutaneous C1-esterase inhibitor [Berinert] enrolled in a prospective registry, 29% had adverse events but most were considered unrelated to therapy including two episodes of thrombotic events, and there were no instances of anaphylaxis; no mention of ALT elevations or hepatotoxicity). 27286778
Longhurst H, Cicardi M, Craig T, Bork K, Grattan C, Baker J, Li HH, Ret al; COMPACT Investigators. Prevention of hereditary angioedema attacks with a subcutaneous C1 inhibitor. N Engl J Med. 2017;376:1131-1140. (Among 90 patients enrolled in a randomized controlled crossover trial of 16 treatment periods of subcutaneous C1-esterase inhibitor [Haegarda] vs placebo for prophylaxis against acute attacks of HAE, numbers of attacks decreased by 76% with 40 IU/kg and 90% with 60 IU/kg given twice weekly, while the overall adverse event rates were similar to that with placebo; one patient on the higher dose developed mild ALT elevations but was also on minocycline). 28328347
Riedl MA, Grivcheva-Panovska V, Moldovan D, Baker J, Yang WH, Giannetti BM, Reshef A, et al. Recombinant human C1 esterase inhibitor for prophylaxis of hereditary angio-oedema: a phase 2, multicentre, randomised, double-blind, placebo-controlled crossover trial. Lancet. 2017;390(10102):1595-1602. (Among 32 patients with HAE treated with recombinant C1-esterase inhibitor [Ruconest: 50 IU/kg] vs placebo once or twice weekly in a cross-over trial of4 week periods, numbers of acute attacks were 2.7 per month with twice weekly, 4.4 per month with once weekly, and 7.2 per month with placebo, while adverse events were mostly headaches, nasopharyngitis, and fatigue and there were no treatment related serious adverse events; no mention of ALT elevations or hepatotoxicity). 28754491
Haegarda--a subcutaneous C1 esterase inhibitor for prevention of hereditary angioedema. Med Lett Drugs Ther. 2018;60(1541):39-40. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of Haegarda, shortly after its approval for use in prevention of attacks of HAE, mentions adverse reactions of hypersensitivity reactions and injection site reactions; no mention of ALT elevations or hepatotoxicity). 29485978
Craig T, Zuraw B, Longhurst H, Cicardi M, Bork K, Grattan C, Katelaris C, et al.; COMPACT Investigators. Long-term outcomes with subcutaneous C1-inhibitor replacement therapy for prevention of hereditary angioedema attacks. J Allergy Clin Immunol Pract. 2019;7:1793-1802.e2. (Among 126 patients in a long term extension study of 40 or 60 IU/kg of subcutaneous C1-esterase inhibitor [Haegarda] given twice weekly, the acute attack rate was 0.4 per month and adverse events were largely injection site reactions, headache, and nasopharyngitis; there were no therapy related serious adverse reactions and no anaphylaxis; no mention of ALT elevations or hepatotoxicity). 30772477
Aygören-Pürsün E, Soteres DF, Nieto-Martinez SA, Christensen J, Jacobson KW, Moldovan D, Van Leerberghe A, et al. A randomized trial of human C1 inhibitor prophylaxis in children with hereditary angioedema. Pediatr Allergy Immunol. 2019;30:553-561. (A randomized crossover trial of two doses [500 or 1000 U] of human plasma derived C1-esterase inhibitor[Cinryze] intravenously twice weekly for prophylaxis of HAE in 12 children ages 6 to 11 years demonstrated a 71% and 85% decrease in acute attacks with mild symptoms of fatigue and irritability but no serious adverse events or discontinuations; no mention of ALT elevations or hepatotoxicity). 30968444
Levy D, Caballero T, Hussain I, Reshef A, Anderson J, Baker J, Schwartz LB, et al. Long-term efficacy of subcutaneous C1 inhibitor in pediatric patients with hereditary angioedema. Pediatr Allergy Immunol Pulmonol. 2020;33:136-141. (Among 10 children with HAE treated with human plasma derived C1-esterase inhibitor [Haegarda: 40 or 60 IU/kg] subcutaneously twice weekly for 1-2 years, all 10 responded with decreases in acute attacks [by 76% to 100%; to 0.11 per month], adverse events being injection site reactions in 3, but there were no serious adverse events, no thrombotic events and no discontinuations). 32953229
Lanadelumab (Takhzyro) for prevention of hereditary angioedema. Med Lett Drugs Ther. 2021 Mar 8;63(1619):e41-e42. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of lanadelumab shortly after its approval for prevention of attacks of HAE, mentions injection site reactions, headache, rash, myalgia, and dizziness, but states that no serious adverse events occurred and makes no mention of ALT elevations or hepatotoxicity). 33755657
Berotralstat (Orladeyo) for prevention of hereditary angioedema. Med Lett Drugs Ther. 2021;63(1629):e7-e8. (Concise review of HAE, the mechanism of action of berotralstat, clinical efficacy, safety, and costs shortly after its approval in the US for prevention of acute attacks of HAE, mentions common adverse events of abdominal pain, vomiting, diarrhea, back pain, and reflux, and the possibility of prolongation of the QTc interval, but does not mention ALT elevations or hepatotoxicity). 34544111
Banerji A, Bernstein JA, Johnston DT, Lumry WR, Magerl M, Maurer M, Martinez-Saguer I, et al.; HELP OLE Investigators. Long-term prevention of hereditary angioedema attacks with lanadelumab: The HELP OLE Study. Allergy. 2022;77:979-990. (Among 212 patients followed for up to 30 months on long term prophylactic therapy against acute attacks of HAE with lanalumab [30 mg every two weeks], the acute attack rate was reduced by 87% compared to baseline, and there were no drug related serious adverse events or deaths, 10 patients developed ALT elevations above 3 times ULN, but all were self-limited in course and not associated with symptoms or jaundice). 34287942
Maurer M, Aberer W, Caballero T, Bouillet L, Grumach AS, Botha J, Andresen I, et al.; IOS Study Group. The Icatibant Outcome Survey: 10 years of experience with icatibant for patients with hereditary angioedema. Clin Exp Allergy. 2022;52:1048-1058. (Among 549 patients with HAE treated with icatibant [30 mg subcutaneously] for 5995 acute attacks in a prospective postmarketing survey, self-administration of the injections was associated with a more rapid resolution of symptoms while adverse events were generally mild-to-moderate and mostly injection site reactions; no mention of ALT elevations or hepatotoxicity). 35861129
Riedl MA, Soteres D, Sublett JW, Desai B, Tomita D, Collis P, Bernstein JA; APeX-S Study Investigators. Hereditary angioedema outcomes in US patients switched from injectable long-term prophylactic medication to oral berotralstat. Ann Allergy Asthma Immunol. 2024;132:505-511.e1. (Among 34 US patients with HAE who were switched from injectable long term prophylaxis [with either a plasma derived C1-esterase inhibitor or lanadelumab] to oral berotralstat monotherapy, the monthly attack rate was 0.29 to 0.58 while mild-to-moderate gastrointestinal adverse events occurred in 35% but there were no serious adverse events; ALT elevations and hepatotoxicity were not mentioned). 38006972

## OTHER REFERENCE LINKS

Recent References on Drugs for HAE: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=hereditary+angioedema+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Drugs for HAE: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=hereditary%20angioedema)